# Histrelin

## OVERVIEW

### Introduction

Histrelin is a gonadotropin releasing hormone (GnRH) agonist that is a potent inhibitor of production of testosterone (in men) and estrogen (in women) and is used predominantly to treat advanced prostate cancer. Histrelin is associated with a low rate of transient serum enzyme elevations during therapy, but has not been linked convincingly to cases of clinically apparent acute liver injury.

### Background

Histrelin (his trel' in) is a nonapeptide analogue of gonadotropin releasing hormone that acts on the pituitary to cause the synthesis and release of luteinizing hormone (LH) and follicle stimulating hormone (FSH), two gonadotropins that act on the male testes to stimulate the production of testosterone and on the female ovaries to induce synthesis of estrogen. Histrelin and other GnRH agonists cause an initial surge of gonadotropin release, but then lead to down-regulation of their synthesis and secretion which results in a decline in testosterone and estrogen production. Histrelin, alone or in combination with other antiandrogens, has been found to be palliative in advanced prostate cancer and as effective as surgical castration. Histrelin was approved for use in the United States in 1991 and as a once-yearly implant formulation in 2004. The major indications for histrelin are advanced prostate cancer and precocious puberty. The GnRH agonists have also been used off label for precocious puberty, infertility, and as a part of gender affirming therapy. Histrelin is available under the brand names Supprelin (for precocious puberty) and Vantas (for prostate cancer; discontinued September 2021) in solution as implants of 50 mg, which are inserted subcutaneously in the inner aspect of the upper arm at 12 month intervals. Histrelin and the other GnRH analogues cause a profound hypogonadism ("chemical castration") and its common side effects are typical of androgen deprivation, including hot flashes, loss of libido, erectile dysfunction, depression, nausea, diarrhea, weight gain and fluid retention. Rare, but potentially severe adverse events include hypersensitivity reactions and transient tumor flare with the first injection.

### Hepatotoxicity

Histrelin has been associated with serum enzyme elevations during therapy in rates similar to those of other GnRH analogues. The serum enzyme elevations are generally mild, asymptomatic and resolve even without dose adjustment or drug discontinuation. ALT elevations above 3 times the upper limit of normal occur in less than 1% of recipients. Histrelin has been linked to a single case of acute liver injury, but it was unclear from the report whether the episode was associated with jaundice or symptoms and other diagnoses remained possible. Thus, clinically apparent liver injury from histrelin may occur, but it is extremely rare and usually self-limited in course. There have been no episodes of acute liver failure, chronic hepatitis or vanishing bile duct syndrome associated with histrelin or other GnRH analogue therapy.

Likelihood score: E* (unproven but suspected rare cause of clinically apparent liver injury).

### Mechanism of Injury

The cause of the minor serum enzyme elevations that can occur during histrelin therapy is unknown. Histrelin is a short peptide similar to GnRH and is metabolized locally in tissue and not by the hepatic cytochrome P450 system. Some serum enzyme elevations may be caused by nonalcoholic fatty liver arising because of weight gain or metabolic changes caused by the androgen deprivation state induced by the GnRH agonist.

### Outcome and Management

The serum enzyme elevations during histrelin therapy rarely require dose modification or drug discontinuation and should instead lead to investigation of other possible causes of liver injury. There is no evidence for cross sensitivity to liver injury among the various GnRH analogues, despite their similarity in chemical structure.

Drug Class: Antineoplastic Agents, GnRH Analogues

Other Drugs in the Subclass, GnRH Analogues: Degarelix, Goserelin, Leuprolide, Relugolix, Triptorelin

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Histrelin – Supprelin®

Histrelin – Vantas®

DRUG CLASS

Antineoplastic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Histrelin)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Histrelin | 76712-82-8 | C66-H86-N18-O12

## ANNOTATED BIBLIOGRAPHY

References updated: 28 May 2023

Abbreviations: FSH, follicle stimulating hormone; GnRH, gonadotropin releasing hormone; LH, luteinizing hormone; PSA, prostate specific antigen.

Zimmerman HJ. Hepatotoxic effects of oncotherapeutic and immunosuppressive agents. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 699. (Expert review of hepatotoxicity published in 1999; GnRH analogues such as histrelin are not discussed).
Chitturi S, Farrell GC. Estrogen receptor antagonists. Adverse effects of hormones and hormone antagonists on the liver. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 610-2. (Review of hepatotoxicity of hormonal products; does not discuss the GnRH agonists such as histrelin).
Levin ER, Vitek WS, Hammes SR. Estrogens, progestins, and the female reproductive tract. In, Brunton LL, Halal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 803-31. (Textbook of pharmacology and therapeutics).
Snyder PJ. Androgens and the male reproductive tract. In, Brunton LL, Halal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 833-43. (Textbook of pharmacology and therapeutics).
Isaacs C, Wellstein A, Riegel AT. Hormones and related agents in the therapy of cancer. In, Brunton LL, Halal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1237-47. (Textbook of pharmacology and therapeutics).
Chertin B, Spitz IM, Lindenberg T, Algur N, Zer T, Kuzma P, Young AJ, et al. (2000). An implant releasing the gonadotropin hormone-releasing hormone agonist histrelin maintains medical castration for up to 30 months in metastatic prostate cancer. J Urol. (Among 21 men with advanced prostate cancer who were treated with a long acting implant of histrelin, LH and testosterone levels were suppressed long term, while adverse events included loss of libido; ALT elevations were not mentioned).
Schlegel PN, Kuzma P, Frick J, Farkas A, Gomahr A, Spitz I, Chertin B, et al. (2001). Effective long-term androgen suppression in men with prostate cancer using a hydrogel implant with the GnRH agonist histrelin. Urology. (Among 42 men with advanced prostate cancer who were treated with 1 to 4 hydrogel implants of histrelin, testosterone suppression lasted for at least 12 months and adverse events included implant site pain or irritation and 50% had hot flashes; there were no serious adverse events attributable to the histrelin and no mention of ALT elevations or hepatotoxicity).
Eugster EA, Clarke W, Kletter GB, Lee PA, Neely EK, Reiter EO, Saenger P, et al. (2007). Efficacy and safety of histrelin subdermal implant in children with central precocious puberty: a multicenter trial. J Clin Endocrinol Metab. (Among 36 children [ages 2 to 11 years] with precocious puberty treated with a 50 mg histrelin implant, peak LH and sex steroid levels were suppressed in all children to prepubertal levels for 12 months in all children and there were no serious adverse events and “no clinically significant findings” in clinical laboratory test results).
Lewis KA, Eugster EA. (2009). Experience with the once-yearly histrelin (GnRHa) subcutaneous implant in the treatment of central precocious puberty. Drug Des Devel Ther. (Review of the use of histrelin implants in management of precocious puberty including results from 3 studies in a total of 78 children mentions that the most common adverse reactions are complications at the implant site, and that there have been "no reported significant abnormalities in...clinical laboratory evaluations").
Deeks ED. (2010). Histrelin: in advanced prostate cancer. Drugs. (Review of the pharmacology, clinical efficacy and safety of histrelin implants which can result in testosterone suppression to castrate levels for up to a year; major side effects are those of androgen deprivation; no mention of ALT elevations or hepatotoxicity).
Ricker JM, Foody WF, Shumway NM, Shaw JC. (2010). Drug-induced liver injury caused by the histrelin (Vantus) subcutaneous implant. South Med J. (69 year old man with prostate cancer developed liver test abnormalities while on ketoconazole and marked worsening one month after placement of a histrelin implant [bilirubin not given, ALT ~1000 U/L, Alk P ~300 U/L], resolving within a month of removal of the implant).
Shore N, Cookson MS, Gittelman MC. (2012). Long-term efficacy and tolerability of once-yearly histrelin acetate subcutaneous implant in patients with advanced prostate cancer. BJU Int. (Review of efficacy and safety of histrelin implant therapy of advanced prostate cancer; mentions side effects of hot flashes, fatigue, testicular atrophy, gynecomastia, decrease in libido and erectile dysfunction, but does not mention ALT elevations or hepatotoxicity).
Van Poppel H, Klotz L. (2012). Gonadotropin-releasing hormone: an update review of the antagonists versus agonists. Int J Urol. (Review of androgen deprivation therapy for prostate cancer using GnRH agonists and antagonists stressing the more rapid onset of action and similar if not better safety profile of GnRH antagonists).
Walker LM, Tran S, Robinson JW. (2013). Luteinizing hormone--releasing hormone agonists: a quick reference for prevalence rates of potential adverse effects. Clin Genitourin Cancer. (Systematic review of adverse event profile of long term use of GnRH agonists which mostly relate to the hormonal changes that occur: hot flashes, gynecomastia, genital shrinkage, hair loss, osteoporosis, mild anemia, hyperglycemia, increased weight, loss of skeletal muscle mass, emotional lability, depression, loss of sexual desire and erectile dysfunction; no mention of ALT elevations or hepatotoxicity).
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. (2013). Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, but none of the 96 were attributed to histrelin or any of the GnRH analogues).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e.7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, none were attributed to histrelin or any of the GnRH analogues).
Silverman LA, Neely EK, Kletter GB, Lewis K, Chitra S, Terleckyj O, Eugster EA. (2015). Long-term continuous suppression with once-yearly histrelin subcutaneous implants for the treatment of central precocious puberty: a final report of a phase 3 multicenter trial. J Clin Endocrinol Metab. (Six year follow up on the 36 children treated with every-12-month histrelin [Eugster 2007], most of whom continued therapy for up to 6 years stated that 53% of children had local pain or discomfort from the implants but they provided prolonged suppression of LH levels and there were no treatment related serious adverse events; no mention of liver injury or ALT levels).
Bolton EM, Lynch TH. (2018). Are all gonadotropin-releasing hormone agonists equivalent for the treatment of prostate cancer? A systematic review. BJU Int. (Systematic review of literature on relative efficacy and safety of different GnRH agonists, indicates that there is little evidence of superiority of any of the four, largely because of lack of adequately powered, controlled studies comparing them).
Cornford P, Jefferson K, Cole O, Gilbody J. (2018). Effects of initiating or switching to a six-monthly triptorelin formulation on prostate cancer patient-healthcare interactions and hospital resource use: a real-world, retrospective, non-interventional study. Oncol Ther. (Among 41 adults with advanced prostate cancer who were switched from every 1 or 3 monthly GnRH regimen to 6 monthly triptorelin, healthcare visits, injections and PSA testing were less as were adverse side effects including fatigue [12% vs 26%], urinary frequency [9% vs 32%], and bone pain [7% vs 14%]; no mention of ALT elevations or hepatotoxicity).
Swendiman RA, Vogiatzi MG, Alter CA, Nance ML. (2019). Histrelin implantation in the pediatric population: A 10-year institutional experience. J Pediatr Surg. (Among 377 children [mean age 9.4 years] undergoing 866 histrelin implant insertions or removals to treat precocious puberty [n=343] or gender affirming therapy [n=34], complications of the procedure were rare [1%] and were largely local wound complications).
Lambertini M, Boni L, Michelotti A, Magnolfi E, Cogoni AA, Mosconi AM, Giordano M, et al., GIM study group. (2022). Long-term outcomes with pharmacological ovarian suppression during chemotherapy in premenopausal early breast cancer patients. J Natl Cancer Inst. (Among 281 women with early onset breast cancer treated with chemotherapy with or without a GnRH analogue to preserve ovarian function, disease-free and overall survival were similar in the two groups and those given the GnRH analogue were slightly more likely to have a successful pregnancy during follow up [6.5% vs 3.2%]; no mention of other adverse events, ALT levels or hepatotoxicity).
Popovic J, Geffner ME, Rogol AD, Silverman LA, Kaplowitz PB, Mauras N, Zeitler P, et al. (2022). Gonadotropin-releasing hormone analogue therapies for children with central precocious puberty in the United States. Front Pediatr. (Review of the 3 GnRH analogues used to treat children with precocious puberty including leuprolide, triptorelin, and histrelin, which have different regimens of administration [intramuscular and subcutaneous] and durations of action [1-12 months]; no mention of liver adverse events).

## OTHER REFERENCE LINKS

1 Recent References on Histrelin: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Histrelin+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Histrelin: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Histrelin)